# Chloroquine

## OVERVIEW

### Introduction

Chloroquine is an aminoquinoline used for the prevention and therapy of malaria. It is also effective in extraintestinal amebiasis and as an antiinflammatory agent for therapy of rheumatoid arthritis and lupus erythematosus. Chloroquine is not associated with serum enzyme elevations and is an extremely rare cause of clinically apparent acute liver injury.

### Background

Chloroquine (klor' oh kwin) was developed in the 1940s as a substitute for quinine in the prophylaxis and treatment of malaria, which had been a major problem among Allied troops in the Pacific. Chloroquine is a synthetic aminoquinoline that acts by binding to the protozoal or parasitic DNA and preventing DNA and RNA production and subsequent protein synthesis; it is active against the asexual erythrocytic forms of Plasmodium and Entamoeba species. Chloroquine is related in structure to quinine but more potent against Plasmodium falciparum, ovale, malariae and vivax, and better tolerated than quinine. Chloroquine remains the first choice of antimalarial prophylaxis as well as treatment. Chloroquine is available in tablets of 250 and 500 mg in generic forms and under the brand name Aralen. The recommended dosage for suppressive prophylaxis is 500 mg once weekly starting 1 to 2 weeks before and continuing for at 4 to 6 weeks after travel to an endemic area. Specific recommendations on the therapy of malaria, including details on diagnosis, drug dosage and safety, are available at the CDC website: https://www.cdc.gov/malaria/. Chloroquine has been replaced by hydroxychloroquine as an antiinflammatory agent in rheumatic diseases, and these are unapproved, off-label uses. Common side effects of chloroquine include headache, blurred vision, anorexia, nausea, diarrhea, skin rash and itching.

In cell culture systems, chloroquine and hydroxychloroquine have been shown to have a spectrum of antiviral activity that is believed to be due to interference with viral binding to glycoprotein cell receptors or inhibition of pH regulation in virus containing endosomes. Indeed, in cell culture both chloroquine or hydroxychloroquine decreased replication of several viruses including the novel coronavirus known as Severe Acute Respiratory Syndrome coronavirus-type 2 (SARS-CoV-2), the cause of the global pandemic of respiratory illness that was first recognized in late 2019 (COVID-19). In face of the growing burden of severe illness posed by COVID-19, chloroquine and hydroxychloroquine were proposed as possibly effective in preventing or ameliorating the course disease and in decreasing mortality. In several case reports, case series and open label trials of these agents yielded evidence of benefit, but in more carefully designed, larger trials neither chloroquine nor hydroxychloroquine given daily for 3 to 5 days had any effect in either preventing infection or ameliorating its outcome.

### Hepatotoxicity

Despite use for more than 50 years, chloroquine has rarely been linked to serum aminotransferase elevations or to clinically apparent acute liver injury. In patients with acute porphyria and porphyria cutanea tarda, chloroquine can trigger an acute attack with fever and serum aminotransferase elevations, sometimes resulting in jaundice. Hydroxychloroquine does not cause this reaction and appears to have partial beneficial effects in porphyria. In clinical trials of chloroquine for COVID-19 prevention and treatment, there were no reports of hepatotoxicity, and rates of serum enzyme elevations during chloroquine treatment were low and similar to those in patients receiving placebo or standard of care.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatic reactions to quinine are usually due to hypersensitivity reactions and chloroquine has occasionally been linked to allergic phenomenon, which may be accompanied by hepatic involvement. Chloroquine undergoes minor metabolism by the liver (~30%) and most is excreted unchanged in the urine.

### Outcome and Management

There does not seem to be cross reactivity to hepatic injury among the various antimalarial agents and switching to other drug can be done.

Drug Class: Antimalarial Agents; see also Hydroxychloroquine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chloroquine – Generic, Aralen®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chloroquine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chloroquine | 54-05-7 | C18-H26-Cl-N3

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2021

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999 mentions that chloroquine has little hepatotoxic effect, except in patients with porphyria cutanea tarda in whom it can cause strikingly elevated ALT levels).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Livingood CS, Dieuaide FR. (1945). Untoward reactions attributable to atabrine. J Am Med Assoc. (Describes several forms of eczematoid dermatitis in soldiers taking atabrine as prophylaxis against malaria in the Pacific theater; rare cases have accompanying severe hepatitis that can be fatal).
Linden IH, Steffen CG, Newcomer VD, Chapman M. (1954). Development of porphyria during chloroquine therapy for chronic discoid lupus erythematosus. Calif Med. (48 year old man with discoid lupus developed symptomatic acute porphyria 3 days after starting chloroquine with fever and uroporphyrins in urine).
Cripps DJ, Curtis AC. (1962). Toxic effect of chloroquine on porphyria hepatica. Arch Dermatol. (3 patients with porphyria had exacerbation of disease after 3-4 days of chloroquine therapy marked by fever, tachycardia, increase in Alk P and porphyrin excretion, with rapid improvement on stopping).
Sweeney GD, Saunders SJ, Dowdle EB, Eales L. (1965). Effects of chloroquine on patients with cutaneous porphyria of the “symptomatic” type. Br Med J. (Administration of chloroquine to 9 patients with porphyria led to fever and AST elevations [as high as 2000 U/L] and mild increases in serum bilirubin in association with increased porphyrin excretion).
Felsher BF, Redeker AG. (1966). Effect of chloroquine on hepatic uroporphyrin metabolism in patients with porphyria cutanea tarda. Medicine(Baltimore). (Chloroquine caused a 3.5 to 28-fold increase in uroporphyrin excretion usually accompanied by fever and ALT elevations [48-69 U/L], with centrolobular necrosis on liver biopsy, thereafter, patients were refractory to the side effects and treatment often induced a clinical remission).
Di Maio VJ, Henry LD. (1974). Chloroquine poisoning. South Med J. (Analysis of 27 cases of fatal overdose of chloroquine from the files of the Armed Forces Institute of Pathology, 13 suicidal, 9 accidental and 1 homicidal; 6 in children ages 1 to 4 years, rapid onset of vomiting, respiratory difficulties and convulsions; largely cardiotoxic).
Thornsvard CT, Guider BA, Kimball DB. (1976). An unusual reaction to chloroquine-primaquine. JAMA. (39 year old woman developed fever abdominal pain, myalgias and red urine 2 days after starting chloroquine-primaquine prophylaxis [bilirubin 0.8 mg/dL, AST >300 U/L, Alk P 60 U/L], porphyrin testing indicated porphyria cutanea tarda).
Cainelli T, Di Padova C, Marchesi L, Gori G, Rovagnati P, Podenzani SA, Bessone E, et al. (1983). Hydroxychloroquine versus phlebotomy in the treatment of porphyria cutanea tarda. Br J Dermatol. (Controlled trial of hydroxychloroquine vs twice monthly phlebotomy in 61 patients with porphyria cutanea tarda; porphyrin excretion was greater with hydroxychloroquine, but worsening liver histology found in both groups).
Stürchler D, Schär M, Gyr N. (1987). Leucopenia and abnormal liver function in travelers on malaria chemoprophylaxis. J Trop Med Hyg. (Analysis of 451 travelers from Switzerland on malarial prophylaxis found higher ALT levels in those on amodiaquine than on chloroquine or no prophylaxis).
Fogh S, Schapira A, Bygbjerg IC, Jepsen S, Mordhorst CH, Kuijlen K, Ravn P, et al. (1988). Malaria chemoprophylaxis in travellers to east Africa: a comparative prospective study of chloroquine plus proguanil with chloroquine plus sulfadoxine-pyrimethamine. Br Med J(Clin Res Ed). (Controlled trial of chloroquine with proguanil vs sulfadoxine-pyrimethamine is 767 travelers to Africa; similar efficacy and side effects; no mention of hepatic adverse events).
Boudreau E, Schuster B, Sanchez J, Novakowski W, Johnson R, Redmond D, Hanson R, et al. (1993). Tolerability of prophylactic malaria regimens. Trop Med Parasitol. (Controlled trial of mefloquine vs chloroquine in 359 US Marines for 12 weeks; no differences in ALT levels between groups; mefloquine had mild psychological side effects and insomnia).
Makin AJ, Wendon J, Fitt S, Portmann BC, Williams R. (1994). Fulminant hepatic failure secondary to hydroxychloroquine. Gut. (Two cases; 27 year old woman developed nausea after 2 weeks of hydroxychloroquine therapy [bilirubin 9.4 mg/dL, ALT 2575 U/L, INR 3.3], followed by progressive liver failure and death in 4 days; 16 year old woman developed jaundice after 2 weeks of hydroxychloroquine therapy [bilirubin 24.4 mg/dL, AST 544 U/L and renal failure], underwent liver transplant but died 6 days later).
Liu AC. (1995). Hepatotoxic reaction to chloroquine phosphate in a patient with previously unrecognized porphyria cutanea tarda. West J Med. (61 year old woman developed nausea and fever 1 day after single dose of chloroquine with red urine [bilirubin 1.1 mg/dL, ALT 2724 U/L, Alk P 115 U/L], later diagnosed as having porphyria cutanea tarda).
Barrett PJ, Emmins PD, Clarke PD, Bradley DJ. (1996). Comparison of adverse events associated with the use of mefloquine and combination of chloroquine and proguanil as antimalarial prophylaxis: a postal and telephone survey of travelers. BMJ. (Mail questionnaire of 3851 British travelers taking mefloquine or chloroquine/proguanil for malaria prophylaxis; side effects similar [~41%], no mention of hepatic events).
Durrheim DN, Gammon S, Waner S, Braacke LE. (1999). Antimalarial prophylaxis: use and adverse events in visitors to the Kruger National Park. S Afr Med J. (Postal survey of 7,397 visitors to Kruger Park in 1996, a chloroquine-resistant area; no mention of hepatic reactions).
van Jaarsveld CHM, Jahangier ZN, Jacobs JWG, Blaauw AAM, van Albada-Kuipers GA, ter Borg EJ, Brus HLM, et al. (2000). Toxicity of antirheumatic drugs in a randomized clinical trial of early rheumatoid arthritis. Rheumatology. (Controlled trial of 4 treatment strategies in 419 patients with early rheumatoid arthritis; side effects were common with ALT elevations in 5 on NSAIDs only, 1 each on gold and hydroxychloroquine, and 20 on methotrexate).
Høgh B, Clarke PD, Camus D, Nothdurft HD, Overbosch D, Günther M, Joubert I, et al., Malarone International Study Team. (2000). Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in non-immune travelers: a randomised, double-blind study. Malarone International Study Team. Lancet. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 1008 travelers; efficacy was similar, but gastrointestinal upset was more common with chloroquine [20% vs 12%]; among 180 with laboratory testing “No clinically important laboratory abnormalities were identified”).
Sarkany RP. (2001). The management of porphyria cutanea tarda. Clin Exp Dermatol. (History, clinical features, pathogenesis, risk factors, complications and management of porphyria cutanea tarda; caused by acquired inhibition of hepatic uroprophyrinogen decarboxylase activity triggered by iron overload, estrogens, or chemicals such as hexachlorobenzene; “Low dose twice weekly chloroquine [125-250 mg] is the mainstay of therapy”).
Angles A, Bagheri H, Montastruc JL, Magnaval JF, Réseau Français des Centres Régionaux de Pharmacovigilance. (2003). Presse Med. (Analysis of adverse reactions to antimalarials reported in France over 5 years; among 508 reports, 4% were hepatic, mostly ALT elevations; one case of hepatitis attributed to halofantrine).
Camus D, Djossou F, Schilthuis HJ, Høgh B, Dutoit E, Malvy D, Roskell NS, et al., International Malarone Study Team. (2004). Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in nonimmune pediatric travelers: results of an international, randomized, open-label study. Clin Infect Dis. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 221 children; efficacy was similar [100%], but side effects were slightly more frequent with chloroquine [mostly gastrointestinal]; no mention of liver injury or ALT elevations).
Taylor WR, White NJ. (2004). Antimalarial drug toxicity: a review. Drug Saf. (Review of the toxicities and side effects of antimalarials mentions that chloroquine can cause worsening of acute porphyria).
Wielgo-Polanin R, Lagarce L, Gautron E, Diquet B, Lainé-Cessac P. (2005). Hepatotoxicity associated with the use of a fixed combination of chloroquine and proguanil. Int J Antimicrob Agents. (50 year old woman developed jaundice four days after starting chloroquine/proguanil for prophylaxis [bilirubin 3.6 mg/dL, ALT 600 U/L, Alk P 744 U/L], resolving within one month, history of previous exposures to both agents).
Rossmann-Ringdahl I, Olsson R. (2007). Porphyria cutanea tarda: effects and risk factors for hepatotoxicity from high-dose chloroquine treatment. Acta Derm Venereol. (Retrospective analysis of 57 patients with porphyria cutanea tarda treated with chloroquine [250 mg/day for 7 days]; ALT rose in all averaging 7 times ULN [range 1.1 to 55 times], with symptoms of fever and arthralgias and increase in porphyrin excretion, higher levels in women; flares followed by remission, but relapse was common during long term follow up).
Giner Galvañ V, Oltra MR, Rueda D, Esteban MJ, Redón J. (2007). Severe acute hepatitis related to hydroxychloroquine in a woman with mixed connective tissue disease. Clin Rheumatol. (26 year old woman with early rheumatoid arthritis developed fever and nausea within 10 hours of starting hydroxychloroquine with ALT 285 U/L [no bilirubin or Alk P levels provided], with rapid resolution, but no recurrence on restarting at a lower dose).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was attributed to artesunate, but no other antimalarial agent was mentioned).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to antimalarials).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antimalarial agent).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an antimalarial agent).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an antimalarial agentl).
(2015). Advice for travelers. Med Lett Drugs Ther. (Concise guidelines on prevention of malaria in travelers indicates that chloroquine is the drug of choice for prevention of malaria in the few areas of the world that still have chloroquine-sensitive malaria).
Wang M, Cao R, Zhang L, Yang X, Liu J, Xu M, Shi Z, et al. (2020). Remdesivir and chloroquine effectively inhibit the recently emerged novel coronavirus (2019-nCoV) in vitro. Cell Res. (In cell culture, both remdesivir and chloroquine demonstrated potential antiviral activity against SARS-CoV-2 at levels achievable in plasma and with minimal cellular cytotoxicity).
Fantini J, Di Scala C, Chahinian H, Yahi N. (2020). Structural and molecular modelling studies reveal a new mechanism of action of chloroquine and hydroxychloroquine against SARS-CoV-2 infection. Int J Antimicrob Agents. (Molecular modeling of the structures of chloroquine and hydroxychloroquine suggest that they would prevent the binding of the SARS-CoV-2 spike protein to its receptor [angiotensin-converting enzyme receptor] on cell membranes and thus prevent viral attachment and infection).
Axfors C, Schmitt AM, Janiaud P, Van't Hooft J, Abd-Elsalam S, Abdo EF, Abella BS, et al. (2021). Mortality outcomes with hydroxychloroquine and chloroquine in COVID-19 from an international collaborative meta-analysis of randomized trials. Nat Commun. (In a metaanalysis of 14 published and 14 unpublished clinical trials including 26 of hydroxychloroquine [10,319 patients] and 4 of chloroquine [307 patients] as therapy of COVID-19, hydroxychloroquine was associated with an excess mortality and chloroquine with no benefit; no separate analysis of adverse events).
WHO Solidarity Trial Consortium. (2021). Repurposed antiviral drugs for Covid-19 – interim WHO Solidarity Trial results. N Engl J Med. (Among 11,300 hospitalized adults with COVID-19 enrolled in randomized controlled trials of four repurposed drugs vs standard of care, none of the 4 agents resulted in reduced mortality rates compared to controls: remdesivir 11% versus 11.2%; hydroxychloroquine 11% vs 9.3%; lopinavir/ritonavir 10.6% vs 10.6%; and interferon beta 11.9% vs 10.5%; and there were no deaths attributed to hepatic disease).

## OTHER REFERENCE LINKS

1 Recent References on Chloroquine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=chloroquine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chloroquine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=chloroquine)